# Penicillins (4th Generation)

## OVERVIEW

The fourth generation penicillins are semisynthetic modifications of natural penicillin that have the advantage of an extended spectrum of activity particularly against gram negative bacteria including Pseudomonas, Enterobacter, Proteus and Klebsiella species. The first generation penicillins are bactericidal antibiotics naturally derived from the mold, Penicillium chrysogenum. Their basic structure includes a thiazolidine ring connected to a beta-lactam ring with a variable side chain. Penicillins bind to bacterial proteins and inhibit synthesis of the bacterial cell wall, causing cell lysis particularly in rapidly growing organisms. Bacterial resistance to penicillin is usually mediated by beta-lactamase, an enzyme which destroys the beta-lactam ring of penicillin, rendering it inactive.

The fourth generation penicillins (sometimes referred to as penicillins with extended spectrum of action) like natural penicillin are susceptible to beta-lactamase. The extended spectrum penicillins are used for therapy of moderate to severe urinary, respiratory, gastrointestinal tract, skin, bone and joint infections. They have activity against Escherichia coli, Hemophilus influenzae, Listeria monocytogenesis, Neisseria gonorrhoeae, Proteus mirabilis, Salmonella, Shigella, Staphylococcus aureus (non-penicillinase producing), Staphylococcus epidermidis, and Streptococcus pneumoniae.

Only one fourth generation penicillin is currently available in the United States: piperacillin (pi" per a sil' in). Several others were used in the United States or Europe, but were abandoned or have been withdrawn (ticarcillin, carbenicillin, mezlocillin and azlocillin). Piperacillin is also available in combination with the beta-lactamase inhibitor tazobactam (taz" oh bak' tam), which provides coverage against penicillinase-resistant bacteria. Piperacillin is a rare cause of acute liver injury and appears to share a common pattern of associated liver injury with other penicillins. Carbenicillin (kar" ben i sil' in), mezlocillin (mez" loe sil' in), and ticarcillin (tye” car sil’ in) fourth generation penicillins that have been withdrawn from use, have also been linked to penicillin-like hepatotoxicity. The combination of ticarcillin with clavulanic acid has been associated with injury that resembles the cholestatic hepatitis that follows therapy with amoxicillin-clavulanate.

Drug Class: Antiinfective Agents

The following extended-spectrum penicillins are discussed separately with individual clinical cases and references. The following are links to each drug record:

- Piperacillin
- Piperacillin-Tazobactam
- Ticarcillin
- Ticarcillin-Clavulanate

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Piperacillin | 59703-84-3 | H26-N5-Na-O7-S
Piperacillin and Tazobactam | 157044-21-8 | C23-H27-N5-O7-S. C10-H12-N4-O5-S.Na
Ticarcillin | 34787-01-4 | C15-H16-N2-O6-S2
Ticarcillin and Clavulanic Acid | 86482-18-0 | C15-H16-N2-O6-S2. C8-H9-N-O5

## ANNOTATED BIBLIOGRAPHY

References updated: 20 October 2020

Zimmerman HJ. Penicillins. In, Hepatotoxicity: The Adverse Effects of Drugs and Other Chemicals on the Liver. 2nd Ed. Philadelphia: Lippincott, 1999. p. 595-6 (Expert review of penicillins and liver injury published in 1999; piperacillin and ticarcillin are listed as associated with elevations in aminotransferase levels, but without reports of clinically apparent liver injury except with ticarcillin-clavulanate).
Moseley RH. Hepatotoxicity of antimicrobials and antifungal agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 463-82. (Review of hepatotoxicity of antibiotics mentions that there have been few case reports of liver injury due to the extended penicillins).
MacDougall C. Penicillins, cephalosporins, and other β-lactam antibiotics. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1023-38. (Textbook of pharmacology and therapeutics).
Pines A, Khaja G, Raafat H, Sreedharan KS. (1974). Preliminary clinical experience with ticarcillin (BRL 2288) in 101 patients treated for severe respiratory infections. Chemotherapy. (Early experience in 101 patients with severe infections given intramuscular ticarcillin; local pain was common and there were minimal and transient elevations in ALT in 4 and Alk P is 5 patients).
Nelson JD, Kusmiesz H, Shelton S, Woodman E. (1978). Clinical pharmacology and efficacy of ticarcillin in infants and children. Pediatrics. (Among 98 children treated with ticarcillin intravenously or intramuscularly, 3 had AST elevations [50-81 U/L] without symptoms or jaundice, and all values decreased during continued treatment).
Brogden RN, Heel RC, Speight TM, Avery GS. (1980). Ticarcillin: a review of its pharmacological properties and therapeutic efficacy. Drugs. (Ticarcillin is a semisynthetic penicillin for parenteral administration similar to carbenicillin; adverse events include skin rash, hypokalemia, eosinophilia and platelet dysfunction; ALT elevations and hepatic injury are not mentioned).
Russo J, Russo ME. (1982). Comparative review of two new wide-spectrum penicillins: mezlocillin and piperacillin. Clin Pharm. (Review of two extended spectrum penicillins, piperacillin is more active than mezlocillin against Pseudomonas, side effect profiles are similar including ALT elevations that occur with both).
González MA. (1982). Comparison of the efficacy and safety of mezlocillin and ticarcillin in the treatment of patients with serious systemic infections. J Antimicrob Chemother. (Randomized clinical trial of mezlocillin vs ticarcillin in 34 patients with severe infections; no mention of ALT elevations).
Parry MF, Neu HC. (1982). The safety and tolerance of mezlocillin. J Antimicrob Chemother. (Analysis of 1148 patients given intravenous mezlocillin for 1 to 52 days; 3.7% had hypersensitivity reactions, 0.9% elevations in ALT, AST or Alk P, but all were reversible and anicteric. In a direct comparison, AST elevations occurred in 1.5% of mezlocillin vs 7.4% of ticarcillin recipients).
Ramírez-Ronda CH, Gutiérrez J, Bermúdez RH. (1982). Comparative effectiveness, safety and tolerance of mezlocillin and ticarcillin: a prospective randomized trial. J Antimicrob Chemother. (Randomized clinical trial comparing mezlocillin [n=21] and ticarcillin [n=20]; no ALT elevations occurred).
Graft DF, Chesney PJ. (1982). Use of ticarcillin following carbenicillin-associated hepatotoxicity. J Pediatr. (3 children who developed elevations in serum ALT levels during intravenous therapy with oxacillin or carbenicillin were then treated with ticarcillin without recurrence of liver injury).
Reed WP, Palmer DL. (1983). Comparison of azlocillin and ticarcillin in the treatment of urinary tract infection. J Antimicrob Chemother. (Randomized clinical trial of azlocillin vs ticarcillin in 35 patients with urinary tract infections, both were highly effective; no mention of ALT elevations or hepatic injury).
Jackson D, Cockburn A, Cooper DL, Langley PF, Tasker TC, White DJ. (1985). Clinical pharmacology and safety evaluation of Timentin. Am J Med. (Toxicological studies of ticarcillin and clavulanate in animals and in pharmacologic studies in humans found no evidence of significant liver injury).
Tasker TC, Cockburn A, Jackson D, Mellows G, White D. Safety of ticarcillin disodium/potassium clavulanate. J Antimicrob Chemother 1986; 17 Suppl C: 225-32. (Preclinical evaluation of ticarcillin found no evidence of significant hepatic injury; early clinical studies found low rate of elevated serum enzymes during therapy, but these may have been due to the underlying illness being treated).
Tan JS, Wishnow RM, Talan DA, Duncanson FP, Norden CW. (1993). Treatment of hospitalized patients with complicated skin and skin structure infections: double-blind, randomized, multicenter study of piperacillin-tazobactam versus ticarcillin-clavulanate. The Piperacillin/Tazobactam Skin and Skin Structure Study Group. Antimicrob Agents Chemother. (Among 251 patients treated with either of 2 fourth generation penicillins, overall rates of response and side effects were similar; no mention of ALT levels of hepatic adverse events).
Schoonover LL, Occhipinti DJ, Rodvold KA, Danziger LH. (1995). Piperacillin/tazobactam: a new beta-lactam/beta-lactamase inhibitor combination. Ann Pharmacother. (Review of pharmacology, efficacy and safety of piperacillin-tazobactam; the most common side effects are diarrhea [8%], nausea, headache, pruritus and rash [1%]; laboratory abnormalities occur in <1% of patients, but can include "transient increases in liver function test results"; no other mention of hepatotoxicity).
Yellin AE, Johnson J, Higareda I, Congeni BL, Arrieta AC, Fernsler D, West J, et al. (2007). Ertapenem or ticarcillin/clavulanate for the treatment of intra-abdominal infections or acute pelvic infections in pediatric patients. Am J Surg. (Among 105 children in a controlled trial, ALT elevations occurred in 3% on ertapenem vs 4% on ticarcillin-clavulanate; no details given).
Devarbhavi H, Dierkhising R, Kremers WK, Sandeep MS, Karanth D, Adarsh CK. (2010). Single-center experience with drug-induced liver injury from India: causes, outcome, prognosis, and predictors of mortality. Am J Gastroenterol. (313 cases of drug induced liver injury were seen over a 12 year period at a large hospital in Bangalore, India; none were attributed to an extended spectrum penicillin).
Ferrajolo C, Capuano A, Verhamme KM, Schuemie M, Rossi F, Stricker BH, Sturkenboom MC. (2010). Drug-induced hepatic injury in children: a case/non-case study of suspected adverse drug reactions in VigiBase. Br J Clin Pharmacol. (Worldwide pharmacovigilance database contained 9036 hepatic adverse drug reactions in children, but ticarcillin and piperacillin were not listed in the top 41 causes).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, none of which were attributed to an extended spectrum penicillin).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, including 15 due to amoxicillin-clavulanate, 1 to dicloxacillin [2nd generation] and 1 to phenoxymethylpenicillin [1st generation], the latter two cases being anicteric; none were attributed to a 4th generation penicillin).
Sistanizad M, Peterson GM. (2013). Drug-induced liver injury in the Australian setting. J Clin Pharm Ther. (Among 17 persons with suspected drug induced liver injury seen over at 12 month period at a referral hospital in Tasmania, 11 were attributed to antibiotics including 4 to flucloxacillin, 2 amoxicillin with clavulanate, 2 amoxicillin, and 1 each to rifampin, moxifloxacin and ciprofloxacin; none to 4th generation penicillins).
Devarbhavi H, Andrade RJ. (2014). Drug-induced liver injury due to antimicrobials, central nervous system agents, and nonsteroidal anti-inflammatory drugs. Semin Liver Dis. (Review of drug induced liver injury from various classes of agents, mentions that amoxicillin-clavulanate is the leading cause of drug induced liver injury, marked by a latency of several days to weeks, often after stopping the antibiotic, the injury varying from cholestatic to hepatocellular and the mortality rate being as high as 7%; no discussion of the 4th generation penicillins).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol. (Systematic review of literature of drug induced liver injury from Latin American countries published between 1996 and 2012 identified 176 cases, of which 37 [19%] were attributed to antimicrobials, including one to benzathine penicillin and 3 to amoxicillin-clavulanate, but none to 4th generation penicillins such as piperacillin or ticarcillin).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 323 [36%] were attributed to antibiotics of which 106 [12%] were due to penicillins including one to 1st, three to 2nd [all due to oxacillin], 97 to 3rd [91 to amoxicillin-clavulanate, and 6 to amoxicillin alone] and five to 4th generation penicillins [all 5 to piperacillin-tazobactam]).
Nicoletti P, Aithal GP, Bjornsson ES, Andrade RJ, Sawle A, Arrese M, Barnhart HX, et al., International Drug-Induced Liver Injury Consortium, Drug-Induced Liver Injury Network Investigators, and International Serious Adverse Events Consortium. (2017). Association of liver injury from specific drugs, or groups of drugs, with polymorphisms in HLA and other genes in a genome-wide association study. Gastroenterology. (A genome wide association study done on 862 Caucasian patients with drug induced liver injury demonstrated a strong link with HLA-A*33:01 in those with cholestatic liver injury, particularly in cases attributed to terbinafine, fenofibrate and ticlopidine).
Cabañas R, Calderon O, Ramirez E, Fiandor A, Prior N, Caballero T, Herránz P, et al. (2014). Piperacillin-induced DRESS: distinguishing features observed in a clinical and allergy study of 8 patients. J Investig Allergol Clin Immunol. (Eight patients with DRESS syndrome attributed to piperacillin-tazobactam were identified at a single Spanish referral center in Madrid between 2006 and 2012; 3 women, 5 men, ages 39 to 83 years, all with rash and eosinophilia, 6 with liver involvement [mixed or cholestatic injury] but none with jaundice, 3 with renal involvement, all survived).
Blumenthal KG, Youngster I, Rabideau DJ, Parker RA, Manning KS, Walensky RP, Nelson SB. (2015). Peripheral blood eosinophilia and hypersensitivity reactions among patients receiving outpatient parenteral antibiotics. J Allergy Clin Immunol. (Among 824 patients who underwent outpatient parenteral antibiotic therapy for at least 2 weeks, 210 [25%] developed eosinophilia including 58 of 207 [28%] who received “penicillins” of whom 3 developed signs of “possible” DRESS syndrome; specific penicillins accounting for the cases were not provided).
Tailor A, Faulkner L, Naisbitt DJ, Park BK. (2015). The chemical, genetic and immunological basis of idiosyncratic drug-induced liver injury. Hum Exp Toxicol. (Review of mechanisms of idiosyncratic drug induced liver injury focusing upon chemically reactive drug metabolites and genetic associations, particularly those with HLA alleles that implicate the adaptive immune response).
Cirulli ET, Nicoletti P, Abramson K, Andrade RJ, Bjornsson ES, Chalasani N, Fontana RJ, et al., Drug-Induced Liver Injury Network (DILIN) investigators. (2019). International DILI consortium (iDILIC). A missense variant in PTPN22 is a risk factor for drug-induced liver injury. Gastroenterology. (Genome wide association studies on 2048 patients with drug induced liver injury and 12,439 controls identified a variant in PTPN22 which was highly associated with liver injury, allele frequency being 0.12 among cases and 0.08 among controls with highest association in Northern Europeans and in cases of amoxicillin clavulanate, PTPN22 being a cellular kinase involved in modulation of immune reactions).

## OTHER REFERENCE LINKS

1 Recent References on Fourth Generation Penicillins: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Ticarcillin/AE+OR+Piperacillin/AE+OR+ticarcillin-clavulanic+acid%5BNM%5D+OR+piperacillin-tazobactam+combination+product%5BNM%5D+)+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI+OR+hepatitis,+toxic%5BMH%5D)+AND+(%222008/03/01%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Fourth Generation Penicillins: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=piperacillin+OR+ticarcillin+OR+(ticarcillin+AND+clavulanic+acid)+OR+(piperacillin+AND+tazobactam))